# Substance Abuse Treatment Agents

## OVERVIEW

The Substance Abuse Treatment Agents are used in combination with structured relapse prevention interventions to treat alcohol, opiate, nicotine and other drug dependencies. These agents are usually not effective on their own and are considered adjunctive therapy to multidisciplinary substance abuse treatment.

The substance abuse treatment agents are generally classified based upon the specific dependency or abuse. Thus, drugs used for maintenance of alcohol withdrawal include disulfiram, acamprosate and naltrexone. Agents used for opiate withdrawal include buprenorphine, methadone and naltrexone. Agents for smoking cessation include nicotine and varenicline. The agents can also be classified as deterrents (disulfiram, naltrexone), neurotransmitter analogues (acamprosate, varenicline), and agents that block withdrawal symptoms (buprenorphine, methadone, nicotine). Disulfiram has been linked to many cases of acute liver injury, some of which are severe and even fatal. The other substance abuse treatment agents have little or no hepatoxic potential unless taken in an overdose (buprenorphine).

The Substance Abuse Treatment Agents in clinical use include the following:

- Acamprosate
- Buprenorphine
- Disulfiram
- Methadone
- Nalmefene
- Naloxegol
- Naloxone
- Naltrexone
- Nicotine
- Varenicline

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 07 September 2021

Zimmerman HJ. Drugs used in aversion therapy. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 724-6. (Expert review of hepatotoxicity published in 1999: discussion of hepatotoxicity of alcohol aversion pharmacotherapy is limited to disulfiram).
Zimmerman HJ. Narcotic analgesics. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 724-6. (Expert review of hepatotoxicity published in 1999 includes discussion of hepatotoxicity of morphine, heroin, methadone, codeine and naltrexone).
Mihic SJ, Koob GF, Mayfield J, Harris RA. Ethanol. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 421-31. (Textbook of pharmacology and therapeutics).
O’Brien. Drug use disorders and addiction. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 433-42. (Textbook of pharmacology and therapeutics).
Mattick RP, Ali R, White JM, O'Brien S, Wolk S, Danz C. (2003). Buprenorphine versus methadone maintenance therapy: a randomized double-blind trial with 405 opioid-dependent patients. Addiction. (Controlled trial in 405 patients with opioid dependence found similar rates of adverse events with buprenorphine and methadone; one patient had hepatitis C, but no other liver related adverse events reported).
Fudala PJ, Bridge TP, Herbert S, Williford WO, Chiang CN, Jones K, Collins J, et al. (2003). Buprenorphine/ Naloxone Collaborative Study Group. Office-based treatment of opiate addiction with a sublingual-tablet formulation of buprenorphine and naloxone. N Engl J Med. (Controlled trial of buprenorphine/naloxone vs buprenorphine alone vs placebo for 4 weeks in 326 opiate addicted patients; ALT elevations occurred in 10 patients, but 8 had concurrent hepatitis B or C).
(2019). Drugs for smoking cessation. Med Lett Drugs Ther. (Concise review of the mechanisms of action, clinical efficacy, safety and costs of drugs for smoking cessation mentions that side effects of varenicline include nausea and constipation, dizziness and headache and sleep disturbances with insomnia and vivid dreams; no mention of ALT elevations or hepatotoxicity).
Goh ET, Morgan MY. (2017). Review article: pharmacotherapy for alcohol dependence – the why, the what and the wherefore. Aliment Pharmacol Ther. (Review of medical therapies for alcohol dependence including disulfiram, a well known cause of acute liver injury, and acamprosate which is not metabolized in the liver, has not been implicated in cases of liver injury, and is generally safe even in persons with impaired hepatic function).